# Fondaparinux

## OVERVIEW

### Introduction

Fondaparinux is a synthetic inhibitor of factor Xa which given by injection and is used as an anticoagulant to treat as well as prevent venous thromboembolism. Fondaparinux has been associated with a low rate of serum aminotransferase elevations during therapy, but has not been implicated in cases of clinically apparent, idiosyncratic liver injury.

### Background

Fondaparinux (fon" da par' in ux) is a synthetic inhibitor of factor Xa which blocks the activity of this clotting factor indirectly by binding to and activating antithrombin III. Fondaparinux is composed of five monomeric sugars that are identical to the sequence present in heparin that comprises the high affinity binding site for antithrombin III. Unlike standard and low molecular weight heparins, however, fondaparinux is specific for factor Xa and has no effect on thrombin or other clotting factors. As a result, fondaparinux has a more predictable and reproducible anticoagulant effect and can be administered in a fixed dose once daily and does not require monitoring for anticoagulant effect. Fondaparinux was approved for use in the United States in 2001 and current indications include prevention of deep vein thromboses in high risk individuals after hip fracture surgery, hip or knee replacement surgery or abdominal surgery and active treatment of deep vein thrombosis with or without pulmonary embolism (in combination with warfarin). Fondaparinux is available as solution for injection in prefilled syringes of 2.5, 5, 7.5 or 10 mg generically and under the brand name Arixtra. The typical dose for prophylaxis of deep vein thrombosis is 2.5 mg subcutaneously once daily for 5 to 30 days. The dose regimen for treatment of deep vein thrombosis and pulmonary embolism is 5 to 10 mg (based upon body weight) subcutaneously once daily for at least 5 days and until a stable INR is achieved with warfarin. Side effects include bleeding and thrombocytopenia, but are less common than with heparin. Noncoagulation related side effects are uncommon but can include anemia, hypokalemia, insomnia, confusion, dizziness, hypotension, rash, and purpura. Rare but potentially severe adverse reactions include severe bleeding episodes including spinal or epidural hematomas.

### Hepatotoxicity

Fondaparinux therapy is associated with a low rate of serum aminotransferase elevations during therapy, with levels above 3 times the upper limit of normal occurring in 1% to 3% of patients, a lower rate than occurs with heparin (~8%) or low molecular weight heparins (4% to 12%) but higher than occurs with placebo (<1%). The liver test abnormalities during fondaparinux therapy were generally mild, not associated with jaundice or symptoms and not requiring drug discontinuation. Typically, liver test abnormalities arose during the first week of therapy and resolved quickly even without dose modification or discontinuation. The abnormalities appear to resemble those that occur with heparin and the low molecular weight heparins. A case reported of marked ALT and AST elevations without jaundice arising within 2 days of starting fondaparinux and resolving rapidly on stopping has been reported. Fondaparinux has not been in wide clinical use, but cases of idiosyncratic clinically apparent liver injury have not been reported in the literature. Thus, while mild-to-moderate serum aminotransferase elevations are common during fondaparinux therapy, clinically apparent liver injury with jaundice has not been reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Fondaparinux may cause a similar direct, self-limited hepatotoxicity as occurs with the use of natural and low molecular weight heparins. If fondaparinux causes idiosyncratic drug induced liver injury, the mechanism of this effect is not known. Fondaparinux has little hepatic metabolism and does not affect CYP 450 enzyme activity in the liver.

### Outcome and Management

The serum aminotransferase elevations that occur during fondaparinux therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No convincing instances of clinically apparent or severe acute liver injury have been linked to fondaparinux in the published literature. Because of its unique chemical structure, it is unlikely that there is cross sensitivity to liver injury with other factor Xa inhibitors such as rivroxaban

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Oral Factor Xa Antagonists: Apixaban, Betrixaban, Edoxaban, Rivaroxaban

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fondaparinux – Generic, Arixtra®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fondaparinux)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fondaparinux | 104993-28-4 | C31-H53-N3-O49-S8

## ANNOTATED BIBLIOGRAPHY

References updated: 22 February 2023

Zimmerman HJ. Heparin. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999 before availability of fondaparinux).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of drugs used in cardiovascular disease; the heparins and fondaparinux are not discussed).
Weitz JI. Blood coagulation and anticoagulant, thrombolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics; fondaparinux is a synthetic five-saccharide analogue of the natural pentasaccharide sequence found in heparin).
(2002). Fondaparinux (Arixtra), a new anticoagulant. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of fondaparinux shortly after its approval for use in the United States; no mention of ALT elevations or hepatotoxicity).
Turpie AG, Bauer KA, Eriksson BI, Lassen MR. (2002). Fondaparinux vs enoxaparin for the prevention of venous thromboembolism in major orthopedic surgery: a meta-analysis of 4 randomized double-blind studies. Arch Intern Med. (Analysis of 4 controlled trials of fondaparinux versus enoxaparin in 7237 patients after orthopedic surgery; rates of side effects were similar in the two groups, but rates of liver injury and ALT elevations were not mentioned).
Büller HR, Davidson BL, Decousus H, Gallus A, Gent M, Piovella F, Prins MH, et al. (2004). Matisse Investigators. Fondaparinux or enoxaparin for the initial treatment of symptomatic deep venous thrombosis: a randomized trial. Ann Intern Med. (Controlled trial of fondaparinux vs enoxaparin in 2205 patients with deep venous thromboses found similar efficacy and safety; no mention of ALT elevations or hepatotoxicity).
Fiessinger JN, Huisman MV, Davidson BL, Bounameaux H, Francis CW, Eriksson H, Lundström T, et al., THRIVE Treatment Study Investigators. (2005). Ximelagatran vs low-molecular-weight heparin and warfarin for the treatment of deep vein thrombosis: a randomized trial. JAMA. (Controlled trial of ximelagatran versus enoxaparin and warfarin in 2489 patients with deep vein thromboses; ALT elevations above 3 times ULN occurred in 9.6% of ximelagatran vs 2% of enoxaparin/warfarin treated patients, and at least one patient on ximelagatran developed clinically apparent liver injury).
Agnelli G, Bergqvist D, Cohen AT, Gallus AS, Gent M, PEGASUS investigators. (2005). Randomized clinical trial of postoperative fondaparinux versus perioperative dalteparin for prevention of venous thromboembolism in high-risk abdominal surgery. Br J Surg. (Among 2048 patients treated with fondaparinux or dalteparin for 5 to 9 days, side effects were similar in the two groups; no discussion of liver injury or ALT elevations).
Turpie AG. (2005). The safety of fondaparinux for the prevention and treatment of venous thromboembolism. Expert Opin Drug Saf. (Review of clinical efficacy and safety of fondaparinux; ALT elevations above 3 times the ULN occurred in 1.3-2.6% of patients on fondaparinux compared to 0.7% on placebo, 3.9-12.3% on enoxaparin, and 8% on heparin; abnormalities were usually asymptomatic and not associated with bilirubin elevations).
Cohen AT, Davidson BL, Gallus AS, Lassen MR, Prins MH, Tomkowski W, Turpie AG, et al. (2006). ARTEMIS Investigators. Efficacy and safety of fondaparinux for the prevention of venous thromboembolism in older acute medical patients: randomised placebo controlled trial. BMJ. (Controlled trial of fondaparinux versus placebo in 849 patients 60 years or older admitted for illness requiring bed rest, no discussion of liver injury or ALT elevations).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to fondaparinux or other anticoagulants).
Decousus H, Prandoni P, Mismetti P, Bauersachs RM, Boda Z, Brenner B, Laporte S, et al., CALISTO Study Group. (2010). Fondaparinux for the treatment of superficial-vein thrombosis in the legs. N Engl J Med. (Among 3002 patients with superficial vein thrombosis in the legs treated with fondaparinux or placebo for 45 days, side effects were similar in the two groups; liver injury and ALT elevations not mentioned).
(2012). Choice of drugs for heparin-induced thrombocytopenia. Med Lett Drugs Ther. (Heparin therapy can cause antibody mediated thrombocytopenia because it binds to platelet factor 4 making it antigenic, a feature not shared by fondaparinux which can be used in patients needing anticoagulation who develop this complication; no mention of ALT elevations or hepatoxicity in discussion of adverse effects).
Orostegui L, Medejel N, Kone-Paut I, Dreyfus M, Benhamou D. (2013). Fondaparinux (Arixtra *) hepatotoxicity in a 6 year-old child. J Hepatol. (5 year old child with a thrombosed vascular malformation developed marked liver test abnormalities 30 hours after starting fondaparinux [bilirubin 0.6 mg/dL, ALT 509 U/L, AST 720 U/L, Alk P 278 U/L], resolving within 5 days of stopping and later tolerating enoxaparin).
Hosaka K, Saito S, Ishii T, Sumino T, Ryu K, Suzuki G, Suzuki T, Tokuhashi Y. (2013). Safety of fondaparinux versus enoxaparin after TKA in Japanese patients. Orthopedics. (Among 277 Japanese patients undergoing total knee replacement treated with enoxaparin or fondaparinux, rates of deep venous thrombosis were similar in the two groups, but ALT elevations were less with fondaparinux [8% vs 30%], but all were transient and without jaundice or symptoms).
(2014). Antithrombotic drugs. Med Lett Drugs Ther. (Concise review of antithrombotic drugs including fondaparinux; discussion of its adverse side effects does not mention ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients With drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 patients with clinically apparent drug induced liver injury enrolled in a US prospective study over an 8 year period, 2 were attributed to antithrombotic agents including 1 to prasugrel [platelet inhibitor] and 1 to dalteparin [low molecular weight heparin], but none to fondaparinux).
Zhang ZH, Zhang JW, He P, Zhou Y, Sun CY. (2017). Fondaparinux is effective for acute portal vein thrombosis in decompensated cirrhotic patients. Medicine (Baltimore). (Among 7 patients with advanced cirrhosis who developed acute portal vein thrombosis and were treated with fondaparinux for variable periods of time, all had recanalization and "no side effects.... occurred in any of the patients").
Yang X, Li N, Guo T, Guan X, Tan J, Gao X, Wu Y, Jia L, et al. (2020). Comparison of the effects of low-molecular-weight heparin and fondaparinux on liver function in patients with pulmonary embolism. J Clin Pharmacol. (Among 463 adults with pulmonary embolus treated with low molecular weight heparins or with fondaparinux, 79 [17%] developed evidence of liver injury that was generally mild and less than 3 times ULN; abnormalities arising in 15% of 377 on edoxaban, 32% of 59 on nadroparin, and 7.4% of 27 on fondaparinux).
Ma J, Chalasani NP, Schwantes-An L, Björnsson ES. (2023). Review article: the safety of anticoagulants and antiplatelet agents in patients with cirrhosis. Aliment Pharmacol Ther. (Review of the safety of anticoagulant use in patients with cirrhosis mentions that drug induced liver injury is uncommon in patients with preexisting cirrhosis, at least in those with compensated [Child’s Class A] or mildly compensated [Child’s Class B] cirrhosis).

## OTHER REFERENCE LINKS

1 Recent References on Fondaparinux: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fondaparinux/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fondaparinux: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fondaparinux)